# Gonadotropins

## OVERVIEW

### Introduction

The gonadotropins are peptide hormones that regulate ovarian and testicular function and are essential for normal growth, sexual development and reproduction. The human gonadotropins include follicle stimulating hormone (FSH) and luteinizing hormone (LH) which are made in the pituitary, and chorionic gonadotropin (hCG) which is made by the placenta. All three gonadotropins are heterodimeric proteins that consist of two peptide chains, the alpha chain is similar in all three, whereas the beta chain is unique and determines the fine receptor specificity and function of each hormone. The pituitary gonadotropins are under the control of gonadotropin releasing hormone (GnRH), a decapeptide produced in the hypothalamus and released in response to circulating levels of estrogens and progesterone. Highly purified and recombinant formulations of the gonadotropins have been developed and used in the treatment of hypogonadism and infertility. Synthetic forms of GnRH have been used with the gonadotropins in assisted reproductive techniques and in vitro fertilization. Therapeutic use of the gonadotropins and GnRH has not been linked to serum enzyme elevations or with clinically apparent liver injury. However, in high doses, the gonadotropins can induce the ovarian hyperstimulation syndrome (OHSS) which may be accompanied by liver test abnormalities, jaundice, edema and ascites.

Follicle stimulating hormone (FSH) is a pituitary hormone that regulates growth, sexual development and reproduction, including menstruation, follicular development and ovulation. FSH is regulated, at least in part, by GnRH produced in the hypothalamus in response to multiple signals including circulating levels of sex hormones. FSH interacts with receptors on ovarian follicles and is the major survival factor for the maturing follicles. A surge in FSH levels occurs in the middle of the menstrual cycle leading to ovulation. In men, FSH promotes spermatogenesis and androgen responsiveness in the testes. Thus, FSH is essential for sexual maturation and reproduction in both men and women. Partially and highly purified urinary derived FSH (menotropins, Menopur which also has LH activity; urofollitropin, Bravelle) and recombinant forms of FSH (follitropin alpha, Follistim, Gonal F) are available and approved for use in treatment of infertility and hypogonadism. They are generally given by subcutaneous injection daily or several times weekly. The dose and appropriate regimen vary by indication. These agents should be used only by health care workers with expertise in management of infertility and hypogonadism.

Luteinizing hormone (LH) is a pituitary hormone that is essential for sexual development and reproduction in both men and women. LH is regulated by GnRH from the hypothalamus which is sensitive to circulating levels of sex hormones. LH interacts with receptors on ovarian follicles and promotes their maturation. In the middle of the menstrual cycle, a surge of LH triggers ovulation and production of progesterone by the corpus luteum that is necessary for the maturation of the uterine endometrium for implantation of the fertilized egg. In males, LH stimulates production of testosterone by the testes. LH is used clinically in assisted reproduction techniques (ART) and in vitro fertilization (IVF) to stimulate ovarian follicle maturation. Both urinary derived (menotropin, Menopur, which also has FSH activity) and recombinant forms (lutropin alfa: Luveris) of human LH have been developed, but not all are available in the United States. LH is generally administered by subcutaneous injection in a cyclic and step-wise fashion. The dosages and regimens of administration vary by indication. These agents should be used only by health care workers with expertise in management of infertility and hypogonadism.

Human chorionic gonadotropin (kor" ee on' ik) (hCG) is a polypeptide hormone produced by the placenta following implantation of the fertilized egg. Circulating human chorionic gonadotropin interacts with the luteinizing hormone receptors of the ovary, promoting the corpus luteum and its production of progesterone which is necessary to maintain pregnancy and support the growth of the fetus. Injections of hCG mimic the surge in LH that is necessary for ovulation and are used in the therapy of female infertility, in assisted reproduction techniques. In clinical trials, hCG resulted in pregnancies in approximately 30% of women. hCG prepared from urine of pregnant women and was approved for use in the United States in 1967 as treatment of ovulatory dysfunction in women desiring pregnancy. Subsequently, recombinant forms of hCG have been developed and licensed for use. Currently, hCG is available as a powder or in solution generically and under trade names such as Novarel and Pregnyl. Recombinant hCG is available as Overle. The dose and regimen of hCG therapy varies by indication and it should be used only by physicians with expertise in the management of infertility and hypogonadism. Common side effects include headache, nausea, anorexia, and local injection reactions. Uncommon, but potentially severe adverse events include ovarian hyperstimulation syndrome.

Gonadotropin releasing hormone (GnRH) is a decapeptide, neurohormone produced in the hypothalamus and released in a pulsatile manner. GnRH acts on the pituitary leading to synthesis and secretion of LH and FSH. GnRH activity is low during childhood and increases markedly during puberty. The proper pulsatile activity of GnRH is necessary for reproduction, but once pregnancy is established it is no longer necessary, gonadotropin activity being assumed by chorionic gonadotropin produced by the placenta. Synthetic GnRH is used as a part of assisted reproductive techniques as a means of controlling ovarian overstimulation. GnRH is available in solution for injection and its use should be restricted to physicians with expertise in assisted reproductive techniques. In addition, several synthetic GnRH analogues and GnRH antagonists have been developed as therapy of various conditions including hormone-sensitive cancers (breast and prostate), endometriosis and precocious puberty. These products are discussed separately in LiverTox as gonadotropin releasing hormone agonists and antagonists.

### Hepatotoxicity

The gonadotropic hormones are usually given in low doses for a short time only and there is little evidence or reason to suspect that they may be hepatotoxic. Injections of LH, FSH, hCG and GnRH, either in short courses or as single injections in assisted reproductive techniques and to stimulate ovulation, have not been linked convincingly to instances of serum enzyme elevations. Even use of more prolonged courses of the gonadotropins for hypogonadism has also not been associated with serum enzyme elevations or other evidence of liver injury. Furthermore, no instances of idiosyncratic, clinically apparent liver injury have been attributed to use of the gonadotropins, alone or in combination.

When used in women for the treatment of infertility, however, the gonadotropins can lead to the ovarian hyperstimulation syndrome (OHSS), severe forms of which can be accompanied by serum enzyme elevations, jaundice and even ascites. This syndrome typically arises within 4 to 14 days of ovarian stimulation with gonadotropins or clomiphene and is characterized by the onset of abdominal pain and distension with ascites and enlarged ovaries and ovarian cysts. There can be marked fluid shifts with hemoconcentration and rapid onset of severe ascites and pleural effusions. Liver tests are elevated in 25% to 40% of patients with OHSS, typically with mild-to-moderate increases in ALT and AST values, but minimal or no elevations in serum bilirubin and alkaline phosphatase levels. The liver test abnormalities resolve with resolution of the OHSS usually within 2 to 3 weeks of onset. In severe instances, OHSS can be fatal, but death is usually due to dehydration, shock and septicemia rather than hepatic failure. In typical cases with abnormal liver enzymes, liver histology reveals nonspecific changes of sinusoidal dilatation, mild fat accumulation and focal inflammatory infiltrates with macrophages and lymphocytes. OHSS is less common with clomiphene than with human chorionic gonadotropin (hCG) induction of ovulation and appears to be more common with the use of FSH and LH. The liver injury that accompanies OHSS is not due to the gonadotropins per se, but rather secondary to their effects on target organs.

Likelihood score [hCG, FSH, LD, GnRH): E (unlikely causes of clinically apparent liver injury but may precipitate evidence of liver injury as a part of the OHSS).

### Mechanism of Injury

A mechanism of injury that might lead to serum enzyme elevations during gonadotropin therapy is not known. The gonadotropins are peptide hormones and are usually metabolized by the cell on which they act. The liver test abnormalities found during OHSS may be due to fluid shifts, hypovolemia and ischemia.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) during gonadotropin therapy should lead to dose reduction or temporary cessation. The gonadotropins and gonadotropin releasing hormone have not been implicated in cases of severe hepatitis, acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no reason to suspect any degree of cross sensitivity in risk for hepatic injury among the various gonadotropins and other agents used to treat infertility.

Drug Class: Obstetrical and Gynecological Agents, Infertility Agents

## CASE REPORT

### Case 1. Jaundice and liver injury during severe ovarian hyperstimulation syndrome.

[Modified from: Obrzut B, Kuczy.ski W, Grygoruk C, Putowski L, Kluz S, Skret A. Liver dysfunction in severe ovarian hyperstimulation syndrome. Gynecol Endocrinol 2005; 21: 45-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/16048801).]

A 32 year old woman with infertility received a cycle of every other day FSH injections followed by a single infusion of hCG for ovulation induction in preparation for natural insemination and presented several days later with nausea, vomiting, abdominal distention and shortness of breath. On examination, she had tachycardia (110/min) and blood pressure was 100/70 mm Hg. She was pale, diaphoretic and had diffuse tenderness and swelling of the abdomen. Laboratory testing suggested hemoconcentration (hematocrit 51%) and hypoproteinemia (total protein 4.8 g/dL). Ultrasonography demonstrated enlarged ovaries with multilocular cysts (14-18 cm), with mild ascites. She received fluids and albumin infusions, but worsened over the next several days, developed jaundice and worsening ascites (Table). A pleural effusion was present on chest X-ray. She underwent repeated paracenteses and was treated with fluids, antibiotics, corticosteroids and heparin. She gradually improved and was discharged after 7 weeks in the hospital. In follow up, she had an uncomplicated pregnancy and delivered a normal child at 38 weeks gestation.

#### Key Points

Medication: | Follicle stimulating hormone and human chorionic gonadotropin injections
Pattern: | Hepatocellular (R=~50)
Severity: | 4+ (jaundice, hospitalization, ascites, intensive care support)
Latency: | Unclear
Recovery: | Complete within 2-3 months
Other medications: | None mentioned

#### Laboratory Values

Hospital Day | ALT* (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Comments
Ovulation induction with FSH and hCG injections
Day 1 | 50 | | 5.0 | Ovarian cysts
Day 3 | 450 | | 2.8 | Worsening ascites
Day 5 | 1050 | | 3.3 | Transfer to ICU care
Day 7 | 2500 | | 1.4
Day 10 | 3372 | 310 | 3.5 | Peak values
Day 13 | 2100 | | 2.8
Day 21 | 2650 | | 1.5
Day 25 | 1800 | | 0.8
Day 31 | 1200 | | 0.8
Day 42 | 40 | | 0.4
8 months | Normal | Normal | Normal | Normal delivery
Normal Values | <40 | <250 | <1.2

* Values estimated from Figure 1, normal values imputed.

#### Comment

The gonadotropins do not seem to be intrinsically hepatotoxic, but they can induce the ovarian hypersensitivity syndrome, severe forms of which may be accompanied by hepatic injury. The pattern of injury is usually a mild jaundice with mild-to-moderate serum enzyme elevations accompanying severe hypoproteinemia and ascites. Recovery usually requires 1 to 4 weeks and follows the resolution of the hyperestrogenism and ovarian hyperstimulation. In this case, there were marked serum aminotransferase elevations with moderate increases in alkaline phosphatase levels, suggesting an element of hypovolemic shock and hepatic ischemic injury. Serial INR, albumin and platelet count results were not provided. The patient ultimately recovered and delivered a "viable" infant after 38 weeks of gestation.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Follicle Stimulating Hormone – Bravelle®

Luteinizing Hormone – Menopur®

Human Chorionic Gonadotropin – Generic, Novarel® Pregnyl®

Gonadotropin Releasing Hormone – Generic

DRUG CLASS

Infertility Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Gonadotropins)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Follicle Stimulating Hormone | 9002-68-0 | Protein | Not Available
Luteinizing Hormone | 9002-67-9 | Protein | Not Available
Human Chorionic Gonadotropin | 9002-61-3 | Protein | Not Available
Gonadotropin Releasing Hormone | 33515-09-2 | Protein | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 26 March 2018

Abbreviations: OHSS, ovarian hyperstimulation syndrome; FSH, follicle stimulating hormone; LH, luteinizing hormone; GnRH, gonadotrophin releasing hormone; hCG, human chorionic gonadotrophin.

Zimmerman HJ. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp 555-88. (Review of hepatotoxicity published in 1999; the gonadotropins are not specifically mentioned).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; gonadotropins and fertility agents are not discussed).
Levin ER, Vitek WS, Hammes SR. Estrogens, Progestins, and the Female Reproductive Tract. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 803-32. (Textbook of pharmacology and therapeutics).
Lunenfeld B, Blankstein J, Kotev-Emeth S, Kokia E, Geier A. Drugs used in ovulation induction. Safety of patient and offspring. Hum Reprod 1986; 1: 435-9. (Review of safety of clomiphene and human chorionic gonadotropin used as therapy of infertility in women to induce ovulation; no mention of ALT elevations or hepatotoxicity). 3106402
Younis JS, Zeevi D, Rabinowitz R, Laufer N, Schenker JG. Transient liver function tests abnormalities in ovarian hyperstimulation syndrome. Fertil Steril 1988; 50: 176-8. (2 women, ages 24 and 28 years, developed abdominal pain and distension, nausea and dyspnea 7 and 16 days after aspiration of oocytes and therapy with human chorionic gonadotropin [bilirubin 0.7 and 0.8 mg/dL, ALT 103 and 124 U/L, Alk P 94 and 115 U/L, albumin 2.0 and 3.3 g/dL], resolving with resolution of the ascites and ovarian enlargement within 3-4 weeks). 3384112
Sueldo CE, Price HM, Bachenberg K, Steinleitner A, Gitlin N, Swanson J. Liver dysfunction in ovarian hyperstimulation syndrome. A case report. J Reprod Med 1988; 33: 387-90. (29 year old woman with infertility developed ascites and OHSS within a week of stopping a course of human menopausal gonadotropin [bilirubin 2.8 mg/dL, ALT 207 rising to 880 U/L, Alk P 111 U/L], liver biopsy was largely normal except for intramitochondrial paracrystaliine inclusions). 3130483
Metrodin and other drugs that induce ovulation. Med Lett Drugs Ther 1988; 30 (775): 91-2. (Concise review of safety and efficacy of drugs used to induce ovulation, including clomiphene and gonadotropins [including urofollitropin]; no mention of ALT elevations or hepatotoxicity, side effects including multiple pregnancies with all agents and OHSS with gonadotropins). 3137426
Gonadorelin for induction of ovulation. Med Lett Drugs Ther 1990; 32 (823): 70-1. (Gonadorelin is a synthetic gonadotropin releasing factor approved for use in treatment of amenorrhea and to induce ovulation, side effects being multiple pregnancies, hypersensitivity reactions and OHSS; no mention of ALT elevations or hepatotoxicity). 2196417
Ryley NG, Forman R, Barlow D, Fleming KA, Trowell JM. Liver abnormality in ovarian hyperstimulation syndrome. Hum Reprod 1990; 5: 938-43. (32 year old woman with infertility treated with human gonadotropin and embryo transfer developed nausea, abdominal distension, marked ascites and hypovolemic shock [peak bilirubin 1.5 mg/dL, AST 255 U/L, Alk P 1173 U/L], biopsy showing fatty change and focal infiltrates, resolving after "evacuation of products"). 1982004
Balasch J, Carmona F, Llach J, Arroyo V, Jové I, Vanrell JA. Acute prerenal failure and liver dysfunction in a patient with severe ovarian hyperstimulation syndrome. Hum Reprod 1990; 5: 348-51. (27 year old woman with infertility developed abdominal pain, distension, ascites, nausea and dyspnea 5 days after follicular aspiration and treatment with hCG [bilirubin rising to 4.4 m/dL, ALT 49 U/L, Alk P 627 U/L], resolving within 2-3 weeks). 2112558
Marsepoil T, Cordesse A, Varguy P, Dauptain G, Levesque P. [Hepatic involvement in the course of ovarian hyperstimulation syndrome]. Rev Fr Gynecol Obstet 1992; 87: 148-9. French. (22 year old woman with infertility developed OHSS shortly after receiving clomiphene and hCG with ascites and pleural effusions [ALT rising to 40 times ULN, bilirubin and Alk P normal], biopsy showing mild portal inflammation and sinusoidal dilatation without hepatocyte necrosis, resolving within 2 months). 1579800
Miura K, Shirasawa H, Nagata S, Komoda F, Nakajima T, Kanai K. Two cases of recurrent hepatic injury associated with early pregnancy: hCG on hepatocytes is a suspected target antigen for lymphocyte attack. Acta Pathol Jpn 1993; 43: 765-73. (Two pregnant women, ages 35 and 23 years, developed liver abnormalities during the second trimester [bilirubin1.1-13.9 mg/dL, ALT 911-2060, Alk P 1-2 times ULN] that resolved after induced abortion in one and spontaneously in another, and was attributed to high circulating levels of hCG based upon positive lymphocyte transformation tests). 8109254
Clinical assessment of recombinant human follicle-stimulating hormone in stimulating ovarian follicular development before in vitro fertilization. Recombinant Human FSH Study Group. Fertil Steril 1995; 63: 77-86. (Among 123 infertile women undergoing in vitro fertilization treated with either recombinant or urinary FSH, success rates were similar and there were no differences in rates of adverse events and no cases of OHSS; no mention of ALT elevations or hepatotoxicity). 7805928
Senturk H, Erdinç S, Tasyurekli M, Mert A, Arvas M, Sen C. Case report: liver function abnormalities in a severe case of hyperreactio luteinalis. J Gastroenterol Hepatol 1996; 11: 617-20. (A 12 week pregnant 19 year old developed multicystic ovarian masses and ascites with rises in liver tests [peak bilirubin 2.0 mg/dL, ALT 214 U/L], resolving within 2-3 weeks). 8840234
Wakim AN, Fox SD. Elevated liver function tests in a case of moderate ovarian hyperstimulation syndrome. Hum Reprod 1996; 11: 588-9. (28 year old woman with infertility was treated with clomiphene and hCG for ovarian stimulation developed abdominal pain and ascites [ALT 183 U/L, bilirubin and Alk P normal], resolving within 2 weeks of onset at time of resolution of ascites). 8671272
Nawroth F, Heinrich J, Bruns U, Wood WG. Severe ovarian hyperstimulation syndrome (OHSS) and icterus. Hum Reprod 1996; 11: 2441-2. (33 year old woman with infertility treated with clomiphene and HCG developed nausea and distended abdomen with ascites and enlarged ovaries [bilirubin rising to 5.2 mg/dL, ALT 184 U/L, Alk P normal], resolving within 2-3 weeks). 8981129
Rizk B, Aboulghar M, Smitz J, Ron-El R. The role of vascular endothelial growth factor and interleukins in the pathogenesis of severe ovarian hyperstimulation syndrome. Hum Reprod Update 1997; 3: 255-66. (Review of OHSS including clinical presentation with massive cystic enlargement of ovaries and fluid shift with ascites, pleural effusions and hypovolemia caused by cytokines and growth factors [VEGF] induced by ovarian stimulation by gonadotropin therapy). 9322101
Bergh C, Howles CM, Borg K, Hamberger L, Josefsson B, Nilsson L, Wikland M. Recombinant human follicle stimulating hormone (r-hFSH; Gonal-F) versus highly purified urinary FSH (Metrodin HP): results of a randomized comparative study in women undergoing assisted reproductive techniques. Hum Reprod 1997; 12: 2133-9. (Comparison of urinary to recombinant FSH in 235 women with infertility found similar rates of successful pregnancy, but better tolerance and more reliable ovarian stimulation with rFSH, while OHSS occurred in 5.2% [rFSH] vs 1.7% [uFSH]). 9402268
Burgués S, Calderón MD. Subcutaneous self-administration of highly purified follicle stimulating hormone and human chorionic gonadotrophin for the treatment of male hypogonadotrophic hypogonadism. Spanish Collaborative Group on Male Hypogonadotropic Hypogonadism. Hum Reprod 1997; 12: 980-6. (60 men with hypogonadism were treated with FSH and hCG by self-injection 2 to 3 times weekly for 6 months; side effects included gynecomastia and headache; serum bilirubin and Alk P levels increased while mean ALT levels decreased during treatment). 9194651
Shimono J, Tsuji H, Azuma K, Hashiguchi M, Fujishima M. A rare case of hepatic injury associated with ovarian hyperstimulation syndrome. Am J Gastroenterol 1998 Jan; 93 (1): 123-4. (26 year old woman treated with menopausal gonadotropin and clomiphene to prevent spontaneous abortion developed massive ascites and multiple ovarian cysts [bilirubin 1.3 mg/dL, ALT 194 U/L] with subsequent resolution, but spontaneous abortion a few weeks later). 9448194
Efficacy and safety of highly purified urinary follicle-stimulating hormone with human chorionic gonadotropin for treating men with isolated hypogonadotropic hypogonadism. European Metrodin HP Study Group. Fertil Steril 1998; 70: 256-62. (Among 28 men with hypogonadism treated with hCG for 3-6 months followed by urinary FSH, 89% achieved spermatogenesis and side effects were uncommon and largely due to increased testosterone levels [acne, weight gain, cryptorchidism]; "clinical chemistry assays...showed no clinically relevant changes"). 9696217
Andoh K, Mizunuma H, Liu X, Kamijo T, Yamada K, Ibuki Y. A comparative study of fixed-dose, step-down, and low-dose step-up regimens of human menopausal gonadotropin for patients with polycystic ovary syndrome. Fertil Steril 1998; 70: 840-6. (Among 37 women with polycystic ovary syndrome treated with various cyclic regimens of FSH injections; one patient developed severe OHSS with ascites). 9806564
Liu PY, Turner L, Rushford D, McDonald J, Baker HW, Conway AJ, Handelsman DJ. Efficacy and safety of recombinant human follicle stimulating hormone(Gonal-F) with urinary human chorionic gonadotrophin for induction of spermatogenesis and fertility in gonadotrophin-deficient men. Hum Reprod 1999; 14: 1540-5. (10 men with hypogonadism were treated with rFSH injections daily after a 6 month course of hCG: "...clinical chemistry variables were normal and entry and no significant changes were observed during treatment"). 10357972
Midgley DY, Khalaf Y, Braude PR, Nelson-Piercy C. Recurrent cholestasis following ovarian hyperstimulation syndrome: case report. Hum Reprod 1999; 14: 2249-51. (34 year old woman with infertility developed OHSS 4 weeks after successful embryo transfer with ascites and enlarged ovaries [ALT 65 U/L], and then at 9 weeks developed pruritus and cholestasis of pregnancy [ALT 215 U/L, elevated bile acids] and then developed preeclampsia and cholestasis again [ALT ~350 U/L], resolving with delivery of normal twins). 10469689
Fábregues F, Balasch J, Ginès P, Manau D, Jiménez W, Arroyo V, Creus M, et al. Ascites and liver test abnormalities during severe ovarian hyperstimulation syndrome. Am J Gastroenterol 1999; 94: 994-9. (Among 50 women with OHSS admitted over a 7 year period to a single referral center, all developed ascites between 4 and 11 days after ovulation induction with gonadotropins, 15 had abnormal liver tests [bilirubin normal, ALT 51-277 U/L, Alk P 83-411 U/L], resolving within 1-3 weeks along with ascites). 10201472
Chen CD, Wu MY, Chen HF, Chen SU, Ho HN, Yang YS. Relationships of serum pro-inflammatory cytokines and vascular endothelial growth factor with liver dysfunction in severe ovarian hyperstimulation syndrome. Hum Reprod 2000; 15: 66-71. (Among 29 women with OHSS after in vitro fertilization, 15 had abnormal liver tests [bilirubin 1.2-2.6 mg/dL, ALT 35-144 U/L, Alk P 64-238 U/L]). 10611190
Frydman R, Howles CM, Truong F. A double-blind, randomized study to compare recombinant human follicle stimulating hormone (FSH; Gonal-F) with highly purified urinary FSH (Metrodin) HP) in women undergoing assisted reproductive techniques including intracytoplasmic sperm injection. The French Multicentre Trialists. Hum Reprod 2000; 15: 520-5. (Controlled trial of rFSH vs uFSH in 278 women undergoing IVF found similar rates of successful live births and similar rate of adverse events, OHSS occurring in 5% [rFSH] vs 2.2% [uFSH]). 10686190
Burgué S; Spanish Collaborative Group on Female Hypogonadotrophic Hypogonadism. The effectiveness and safety of recombinant human LH to support follicular development induced by recombinant human FSH in WHO group I anovulation: evidence from a multicentre study in Spain. Hum Reprod 2001; 16: 2525-32. (Open label study of recombinant FSH and LH in 38 anovulatory women found a high rate of follicular development and few side effects including 3 cases of OHSS: "treatment did not cause significant changes in haematological, biochemical or urinary parameters"). 11726569
Chang P, Kenley S, Burns T, Denton G, Currie K, DeVane G, O'Dea L. Recombinant human chorionic gonadotropin (rhCG) in assisted reproductive technology: results of a clinical trial comparing two doses of rhCG (Ovidrel) to urinary hCG (Profasi) for induction of final follicular maturation in in vitro fertilization-embryo transfer. Fertil Steril 2001; 76: 67-74. (Among 297 infertile women undergoing assisted reproduction techniques who received either urinary hCG or one of two doses of recombinant hCG, efficacy was better with the higher dose, but side effects were more common including OHSS in 3% after uhCG and 3% and 9% after low and high dose rhCG in whom ALT levels were usually increased). 11438321
European Recombinant LH Study Group. Human recombinant luteinizing hormone is as effective as, but safer than, urinary human chorionic gonadotropin in inducing final follicular maturation and ovulation in in vitro fertilization procedures: results of a multicenter double-blind study. J Clin Endocrinol Metab 2001; 86: 2607-18. (Among 259 infertile women treated with rFSH for ovarian stimulation received one of 4 doses of rLH or uhCG for final follicular maturation, success rates were similar with all regimens, but OHSS was less in those who received a single dose of rLH compared to multiple doses or urinary hCG). 11397861
International Recombinant Human Chorionic Gonadotropin Study Group. Induction of ovulation in World Health Organization group II anovulatory women undergoing follicular stimulation with recombinant human follicle-stimulating hormone: a comparison of recombinant human chorionic gonadotropin (rhCG) and urinary hCG. Fertil Steril 2001; 75: 1111-8. (Controlled trial of injections of recombinant vs urinary hCG in 198 women undergoing ovarian stimulation with FSH found that local reactions were less with rhCG but all 3 cases of OHSS occurred with its use). 11384635
Elter K, Scoccia B, Nelson LR. Hepatic dysfunction associated with moderate ovarian hyperstimulation syndrome. A case report. J Reprod Med 2001; 46: 765-8. (33 year old woman with infertility developed abdominal distension, ascites and OHSS 11 days after embryo transfer with daily injections of leuprolide and several injections of FSH, hCG and progesterone [ALT 265 U/L, bilirubin and Alk P normal] resolving in 1-2 weeks). 11547654
Davis AJ, Pandher GK, Masson GM, Sheron N. A severe case of ovarian hyperstimulation syndrome with liver dysfunction and malnutrition. Eur J Gastroenterol Hepatol 2002; 14: 779-82. (28 year old woman with infertility developed abdominal pain and distension 1 day after embryo transfer [bilirubin 0.6 mg/dL, ALT 462 U/L, Alk P 706 U/L, prothrombin time 19 sec], resolving over the ensuing 3 weeks). 12169989
Liu PY, Wishart SM, Handelsman DJ. A double-blind, placebo-controlled, randomized clinical trial of recombinant human chorionic gonadotropin on muscle strength and physical function and activity in older men with partial age-related androgen deficiency. J Clin Endocrinol Metab 2002; 87: 3125-35. (Controlled trial of hCG vs placebo injected twice weekly for 3 months in 40 older men with partial androgen deficiency, found increases in serum testosterone and decreases in LH and FSH, but no improvement in muscle strength or sexual function and slight increase in body weight; no mention of ALT elevations or hepatotoxicity). 12107212
Dickey RP, Thornton M, Nichols J, Marshall DC, Fein SH, Nardi RV; Bravelle IVF Study Group. Comparison of the efficacy and safety of a highly purified human follicle-stimulating hormone (Bravelle) and recombinant follitropin-beta for in vitro fertilization: a prospective, randomized study. Fertil Steril 2002; 77: 1202-8. (Controlled trial of recombinant vs urinary FSH injections in 177 women undergoing in vitro fertilization found similar rates of efficacy and side effects with 6 cases of OHSS, one of them severe; no mention of ALT elevations or hepatotoxicity). 12057729
Bouloux P, Warne DW, Loumaye E; FSH Study Group in Men's Infertility. Efficacy and safety of recombinant human follicle-stimulating hormone in men with isolated hypogonadotropic hypogonadism. Fertil Steril 2002; 77: 270-3. (Among 19 infertile men treated with recombinant FSH injected 3 times weekly for 18 months to stimulate spermatogenesis, side effects were largely due to increase in testosterone levels; no mention of ALT elevations or hepatotoxicity). 11821082
Delvigne A, Rozenberg S. Review of clinical course and treatment of ovarian hyperstimulation syndrome (OHSS). Hum Reprod Update 2003; 9: 77-96. (Review of OHSS mentions that liver abnormalities occur in 26-40% of cases, typically with elevations in ALT, but normal bilirubin and Alk P values, resolving in all cases with resolution of the syndrome). 12638783
López E, Gunby J, Daya S, Parrilla JJ, Abad L, Balasch J. Ovulation induction in women with polycystic ovary syndrome: randomized trial of clomiphene citrate versus low-dose recombinant FSH as first line therapy. Reprod Biomed Online 2004; 9 (4): 382-90. (Among 76 women with infertility and polycystic ovarian syndrome treated with 3 cycles of either low dose rFSH or clomiphene to induce follicular development, 2 cases of mild OHSS occurred in the rFSH treated patients and none with clomiphene; other adverse events were not mentioned). 15511336
Keye WR, Webster B, Dickey R, Somkuti S, Crain J, Scobey MJ. Subcutaneously administered Menopur, a new highly purified human menopausal gonadotropin, causes significantly fewer injection site reactions than Repronex in subjects undergoing in vitro fertilization. Reprod Biol Endocrinol 2005; 3: 62. (Among 125 women with infertility treated with leuprolide and one of two forms of human urinary menopausal gonadotropins for up to 12 days before hCG administration, side effects were with the two products, except for fewer injection site reactions with the more highly purified preparation; no mention of ALT elevations of hepatotoxicity). 16280073
Abdelmassih V, Oliveira FG, Goncalves SP, Varella AD, Diamond MP, Abdelmassih R. A prospective, randomized and blinded comparison between 10,000 IU urinary and 250 microg recombinant human chorionic gonadotropin for oocyte maturation in in vitro fertilization cycles. J Assist Reprod Genet 2005; 22: 149-53. (Controlled trial of single injections of urinary vs recombinant hCG for oocyte maturation in 100 women with infertility found similar efficacy, but more local injection site reactions with uhCG [38%] than rhCG [13%]; no mention of ALT elevations or hepatotoxicity). 16021858
Obrzut B, Kuczy.ski W, Grygoruk C, Putowski L, Kluz S, Skret A. Liver dysfunction in severe ovarian hyperstimulation syndrome. Gynecol Endocrinol 2005; 21: 45-9. (32 year old woman with infertility developed severe OHSS with marked ascites, dyspnea and hypovolemia after therapy with clomiphene and hCG [bilirubin 5 mg/dL, ALT 3372 U/L, Alk P 310 U/L], with full recovery over the ensuing month). 16048801
Binder H, Dittrich R, Einhaus F, Krieg J, MüA, Strauss R, Beckmann MW, Cupisti S. Update on ovarian hyperstimulation syndrome: Part 1--Incidence and pathogenesis. Int J Fertil Womens Med 2007; 52: 11-26. (Review of OHSS, which arises in 0.2-1% of stimulation cycles in assisted reproduction and may be mediated by VEGF levels of which correlate with hCG levels; liver enzyme elevations, predominantly ALT and AST, arise in 25-40% of cases possibly due to the increased capillary permeability of OHSS). 17987884
Kaufmann R, Dunn R, Vaughn T, Hughes G, O'Brien F, Hemsey G, Thomson B, O'Dea LS. Recombinant human luteinizing hormone, lutropin alfa, for the induction of follicular development and pregnancy in profoundly gonadotrophin-deficient women. Clin Endocrinol (Oxf) 2007; 67: 563-9. (Injections of recombinant LH and FSH were given to 31 hypogonadal women in 54 cycles of 9 to 28 days and achieved follicular development in 87%; "There were no clinically significant abnormalities for any of the blood chemistry...parameters assessed"). 17692110
Moon SY, Choi YS, Ku SY, Kim SH, Choi YM, Kang IS, Kim CH. Comparison of the efficacy and safety of a new recombinant human follicle-stimulating hormone (DA-3801) with follitropin-alpha (Gonal-F) in women undergoing controlled ovarian hyperstimulation for assisted reproductive technology. J Obstet Gynaecol Res 2007; 33: 305-15. (Controlled trial of two formulations of rFSH in 97 women undergoing ovarian stimulation found similar rates of efficacy and side effects; there were minor changes in ALT and Alk P levels, "but these changes were within reference ranges and not clinically significant"). 17578360
Shoham Z, Smith H, Yeko T, O'Brien F, Hemsey G, O'Dea L. Recombinant LH (lutropin alfa) for the treatment of hypogonadotrophic women with profound LH deficiency: a randomized, double-blind, placebo-controlled, proof-of-efficacy study. Clin Endocrinol (Oxf) 2008; 69: 471-8. (Among 39 women with infertility treated with recombinant FSH and either recombinant LH or placebo in an attempt to stimulate follicular development, the addition of rLH provided a higher rate of follicular development, but no difference in rates of adverse events; one placebo recipient had a transient ALT elevation). 18485121
Drugs for ovulation induction. Med Lett Drugs Ther 2011; 53 (1376): 86-8. (Concise review of the efficacy and safety of drugs used for ovarian induction mentions that common side effects of FSH, LH and hCG include injection site reactions, headache, abdominal pain and nausea, and that FSH and LH can cause OHSS which can be severe and even fatal; no mention of ALT elevations or hepatotoxicity). 22033212
Ashrafi M, Kiani K, Ghasemi A, Rastegar F, Nabavi M. The effect of low dose human chorionic gonadotropin on follicular response and oocyte maturation in PCOS patients undergoing IVF cycles: a randomized clinical trial of efficacy and safety. Arch Gynecol Obstet 2011; 284: 1431-8. (Among 90 women with polycystic ovary syndrome undergoing assisted reproduction treated with FSH and with one of three regimens of hCG to induce ovulation, severe OHSS occurred only in those in whom FSH was continued in full dosage). 21210134
Checa MA, Espinós JJ, Requena A. Efficacy and safety of human chorionic gonadotropin for follicular phase stimulation in assisted reproduction: a systematic review and meta-analysis. Fertil Steril 2012; 97: 1343-50. e1-3. (Systematic review of the literature on use of hCG for follicular phase stimulation identified 11 relevant publications; discussion of adverse events was restricted to miscarriage and OHSS, neither of which was more frequent with hCG than with comparator treatments such as FSH and LH). 22464087
Alviggi C, Cognigni GE, Morgante G, Cometti B, Ranieri A, Strina I, Filicori M, et al. A prospective, randomised, investigator-blind, controlled, clinical study on the clinical efficacy and tolerability of two highly purified hMG preparations administered subcutaneously in women undergoing IVF. Gynecol Endocrinol 2013; 29: 695-9. (Among 157 women receiving one of two menopausal gonadotropin preparations as a part of assisted reproductive techniques, success rates and adverse event rates were similar, two women developed mild OHSS, no mention of ALT elevations or hepatotoxicity). 23638621
Figueiredo JB, Nastri CO, Vieira AD, Martins WP. Clomiphene combined with gonadotropins and GnRH antagonist versus conventional controlled ovarian hyperstimulation without clomiphene in women undergoing assisted reproductive techniques: systematic review and meta-analysis. Arch Gynecol Obstet 2013; 287: 779-90. (Review of 7 studies comparing the safety of regimens to induce ovulation with or without clomiphene mentions that OHSS is less common in regimens that include clomiphene [0.5% vs 4%]). 23250342
Bellavia M, de Geyter C, Streuli I, Ibecheole V, Birkhäer MH, Cometti BP, de Ziegler D. Randomized controlled trial comparing highly purified(HP-hCG) and recombinant hCG (r-hCG) for triggering ovulation in ART. Gynecol Endocrinol 2013; 29: 93-7. (Among 147 women receiving either recombinant or highly purified urinary hCG preparations while undergoing assisted reproductive techniques, adverse event rates were similar and 5 women developed moderate-to-severe OHSS; no mention of ALT elevations or hepatotoxicity). 23116325
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to gonadotropins or arose as a complication of assisted reproductive techniques). 25754159
Practice Committee of the American Society for Reproductive Medicine. Prevention and treatment of moderate and severe ovarian hyperstimulation syndrome: a guideline. Fertil Steril 2016; 106: 1634-47. (Guidelines on management and prevention of OHSS, an uncommon but serious complication of assisted reproductive techniques occuring in 1-5% of cycles, severe instances accompanied by abdominal pain, ascites and liver enzyme elevations; rates are higher with GnRH agonists than antagonists). 27678032
Humaidan P, Chin W, Rogoff D, D'Hooghe T, Longobardi S, Hubbard J, Schertz J; ESPART Study Investigators. Efficacy and safety of follitropin alfa/lutropin alfa in ART: a randomized controlled trial in poor ovarian responders. Hum Reprod 2017; 32: 544-55. (Among 939 women who had a poor response to ovarian stimulation during assisted reproductive technology [ART] and who underwent repeat ART with either recombinant hFSH alone or its combination with recombinant hLH, rates of oocyte retrieval were similar as were adverse event rates; only one patient developed OHSS which was mild and self-limited). 28137754

## OTHER REFERENCE LINKS

1. Recent References on Gonadotropins, Gonadotropin Releasing Hormone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Gonadotropins/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221998/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Gonadotropins, Gonadotropin Releasing Hormone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Gonadotropins)